# Greater Celandine

## OVERVIEW

### Introduction

Greater celandine is a botanical extract derived from a plant of the Poppy family that is typically used for the treatment of gastrointestinal disorders and dyspepsia. Celandine has been linked to several instances of clinically apparent liver injury.

### Background

Greater celandine (Chelidonium majus) is a plant of the Poppy family (Papaveraceae) which grows wild in Asia and Europe and has been introduced widely in the United States. Leaf extracts may contain up to 20 alkaloids, including benzophenanthridines, protoberberines and hydroxycinnamic acid derivatives. For centuries, celandine has been used to treat gastrointestinal complaints, dyspepsia and gallbladder disease. The chemical compound responsible for the antispasmodic activity of greater celandine is unknown. Celandine also acts as a mild sedative and it has been used to treat asthma, bronchitis and whooping cough. In recent years, greater celandine extracts have been used largely as therapy for dyspepsia and gallbladder disease, but it has also been claimed to be beneficial for skin conditions, asthma and bronchitis and as a weight loss agent. No human studies have been done that substantiate the benefits of celandine in these conditions or to define its safety, tolerability and adverse effects.

Lesser celandine (Ranunculus ficaria or Ficaria verna), also known as fig celandine, is a flowering plant native to Europe and Western Asia that is unrelated to greater celandine. Lesser celandine belongs to the buttercup family and has brightly colored yellow petals. The plant is poisonous to domesticated grazing animals and considered an undesirable weed. Extracts of lesser celandine are astringents that are used topically to treat hemorrhoids (hence its common name “pilewort”). It is rarely taken as an oral herbal product.

### Hepatotoxicity

Over a dozen publications, largely from Europe, have described clinically apparent acute liver injury attributable to greater celandine (Chelidonium majus). Liver injury typically arises after 1 to 6 months, with jaundice and moderate to marked elevations in serum aminotransferase levels. The pattern of injury is usually hepatocellular and the clinical presentation and liver histology resemble acute viral hepatitis. Immunoallergic features are uncommon, but autoantibodies may be present in low to moderate levels in many cases. The clinical syndrome, however, rarely resembles autoimmune hepatitis and usually resolves rapidly once the botanical is discontinued and without need of corticosteroid therapy. There have been no reports of greater celandine hepatotoxicity from the United States or the Americas.

Likelihood Score: B (uncommon but likely cause of clinically apparent liver injury).

### Mechanism of Injury

Greater celandine extracts have many components, but none of them has been shown to be specifically hepatotoxic. The rare cases of liver injury due to greater celandine have had idiosyncratic features.

### Outcome and Management

Hepatotoxicity from greater celandine is rare; some cases have been severe, but fatal cases and acute liver failure leading to liver transplantation has not been described. Recurrence with reexposure has been documented in several cases and rechallenge should be avoided.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Acute hepatitis due to greater celandine.(1)

A 42 year old woman developed fever, muscle aches, headaches, fatigue and abdominal discomfort 2 weeks after starting an oral herbal preparation containing greater celandine (Chelidonium majus) for a skin condition. The fever resolved in two weeks, but she continued to have generalized fatigue and then developed dark urine, light colored stools and jaundice. She sought medical care and the herbal preparation was discontinued. She had no history of liver disease, did not drink alcohol and denied risk factors for viral hepatitis. She was taking no other medications. On examination, she was jaundiced but had no signs of chronic liver disease. Laboratory results showed normal blood counts, but hyperbilirubinemia (~8.1 mg/dL) and marked elevations in serum ALT (~2900 U/L). Because of worsening jaundice, she was transferred to a referral hospital (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Immunoglobulin levels were normal. Liver ultrasound showed no evidence of biliary obstruction. A liver biopsy showed lymphocytic infiltrates and spotty necrosis with cell drop out in central areas with cholestasis. Thereafter, she improved symptomatically and in follow up her liver tests returned to the normal range.

#### Key Points

Medication: | Greater celandine (Chelidonium majus)
Pattern: | Hepatocellular (R=11.7, at week 9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks to symptoms, 5 weeks to jaundice
Recovery: | 8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L)* | AST; (U/L)* | Bilirubin; (mg/dL)* | Comments
| | Started celandine for skin disorder
5 weeks | 0 | 3200 | | 8.2 | Celandine stopped
8 weeks | 3 weeks | 2900 | | 10.8 | Hospital transfer
9 weeks | 4 weeks | 1490 | 265 | 11.7
10 weeks | 5 weeks | 700 | | 7.0 | Liver biopsy
13 weeks | 8 weeks | 29 | 115 | 1.3
Normal Values | | <30 | <120 | <1.2

* Values estimated from Figure 2 (laboratory parameters are mislabeled).

#### Comment

The case history is typical of greater celandine hepatotoxicity. Other causes of acute liver injury were appropriately excluded. The onset of injury within 2 to 5 weeks of starting and resolution within 8 weeks of stopping the herbal product provides good evidence that the liver injury was caused by it. Rechallenge is not necessary for the diagnosis; other cases of celandine hepatotoxicity have demonstrated recurrence upon rechallenge. Greater celandine was used widely in Europe but rarely in the United States, so virtually all published cases are from Europe, including Germany, Spain, Italy, Belgium and the Netherlands.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Greater Celandine – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Greater Celandine | 84603-56-5 | Herbal mixture | Not applicable

## CITED REFERENCES

1 Crijns AP, de Smet PA, van den Heuvel M, Schot BW, Haagsma EB. (2002). Ned Tijdschr Geneeskd.

## ANNOTATED BIBLIOGRAPHY

References updated: 24 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of herbals is discussed but not greater celandine specifically).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that greater celandine has been used in Europe to treat dyspepsia and gallstones and that multiple cases of acute hepatitis including a case series of 10 instances attributable to celandine have been published).
Celandine (Chelidonium majus). In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 180-1. (Compilation of short monographs on herbal medications and dietary supplements).
Pinto García V, Vicente PR, Barez A, Soto I, Candas MA, Coma A. (1990). Sangre(Barc). (72 year old woman developed hemolytic anemia and renal dysfunction with hepatic involvement after taking greater celandine [bilirubin 1.7 mg/dL, ALT 538 U/L], resolving rapidly upon stopping).
De Smet PA, Van den Eertwegh AJ, Lesterhuis W, Stricker BH. (1996). Hepatotoxicity associated with herbal tablets. BMJ. (69 year old woman developed jaundice six weeks after starting herbal tablets “Venencapsan” prepared locally from horse chestnut leaf, milfoil, celandine, sweet clover, milk thistle and dandelion root, recurring on reexposure [bilirubin 1.6 and 4.7 mg/dL, ALT 244 and 1004 U/L, Alk P 229 and 250 U/L], and resolving rapidly on stopping).
Strahl S, Ehret V, Dahm HH, Maier KP. (1998). Dtsch Med Wochenschr. (42 year old woman developed repeated bouts of jaundice 6 months and then 6 weeks after staring celandine [bilirubin 3.6 and 4.4 mg/dL, ALT 427 and 389 U/L, GGT 87 U/L, Alk P 221 U/L], resolving within 2 months of stopping each time).
Greving I, Meister V, Monnerjahn C, Müller KM, May B. (1998). Chelidonium majus: a rare reason for severe hepatotoxic reaction. Pharmacoepidemiol Drug Saf. (Two cases: a 28 year old woman developed jaundice and itching 5 months after starting greater celandine [bilirubin 16.4 mg/dL, ALT 432 U/L], resolving in 2 months; 35 year old woman developed jaundice and abdominal pain 4 months after starting celandine [bilirubin 16.1 mg/dL, ALT 654 U/L], resolving within a few months of stopping).
Benninger J, Schneider HT, Schuppan D, Kirchner T, Hahn EG. (1999). Acute hepatitis induced by greater celandine (Chelidonium majus). Gastroenterology. (Report of 10 cases of hepatitis attributed to greater celandine; all women, ages 37 to 67 years, taking celandine for digestive disorders or eczema for 1-9 months, presented with symptoms [bilirubin normal in 5 and 4.5-21.7 mg/dL in the rest, ALT 123-1338 U/L, Alk P 65-451 U/L], resolving within 2-6 months in all; one patient had recurrence on restarting celandine).
Chitturi S, Farrell GC. (2001). Drug-induced cholestasis. Semin Gastrointest Dis. (Review of hepatotoxicity manifested by prominent cholestatic features; discusses greater celandine, although usual presentation is with an acute hepatitis-like syndrome).
Stickel F, Seitz HK, Hahn EG, Schuppan D. (2001). Z Gastroenterol. (Review of hepatotoxicity of botanicals including pyrrolizidine alkaloids, germander, greater celandine, chaparral, Chinese herbs and pennyroyal).
De Smet PA. (2002). Safety concerns about kava not unique. Lancet. (Letter indicating that greater celandine like kava has been linked to several cases of severe liver injury and a warning label was added in Germany).
Crijns AP, de Smet PA, van den Heuvel M, Schot BW, Haagsma EB. (2002). Ned Tijdschr Geneeskd. (42 year old woman developed fever and abdominal pain 2 weeks after starting greater celandine, followed by fatigue and jaundice at 5 weeks [bilirubin 8.1 rising to 11.7 mg/dL, ALT 2900 U/L, Alk P 265 U/L], worsening for a few weeks and then resolving 2 months after stopping: Case 1).
van Noordwijk J. (2002). Ned Tijdschr Geneeskd. (Editorial in response to Crijns [2002] “Search first for a poison, or for a plant product”; plant products are not necessarily safer than prescription medications).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbal medications, including discussion of potential risk factors, and herb-drug interactions; greater celandine has been implicated in 10 cases of acute hepatitis with onset within 3 months in most and resolution in all, generally within 2 to 6 months of stopping).
Stickel F, Pöschl G, Seitz HK, Waldherr R, Hahn EG, Schuppan D. (2003). Acute hepatitis induced by Greater Celandine (Chelidonium majus). Scand J Gastroenterol. (2 cases: 39 year old woman developed jaundice 4 weeks after starting celandine [bilirubin 7.1 rising to 13.5 mg/dL, ALT 912 U/L, Alk P 116 U/L], with recurrence on restarting and resolution in 7 weeks on stopping; 69 year old man developed jaundice 6 weeks after starting celandine [bilirubin 9.1 mg/dL, ALT 881 U/L, Alk P 312 U/L], with resolution on stopping).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation and a specific discussion of greater celandine).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being greater celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal oil [1], skullcap [2], Chinese herbs [9], valerian [1]).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals: none were attributed to celandine).
Pak E, Esrason KT, Wu VH. (2004). Hepatotoxicity of herbal remedies: an emerging dilemma. Prog Transplant. (Review of hepatotoxicity of herbal medications stressing the recent rise in numbers of cases, with literature review of cases due to greater celandine).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but celandine not mentioned as a cause).
Rifai K, Flemming P, Manns MP, Trautwein C. (2006). Internist (Berl). (58 year old man developed jaundice and pruritus 3 weeks after starting greater celandine [bilirubin 9.6 mg/dL, ALT 903 U/L], resolving within 4 weeks of stopping).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, with a review of the 13 cases of acute liver injury attributed to greater celandine in the literature).
Hardeman E, Van Overbeke L, Ilegems S, Ferrante M. (2008). Acute hepatitis induced by greater celandine (Chelidonium majus). Acta Gastroenterol Belg. (58 year old woman developed jaundice 3 weeks after starting greater celandine [bilirubin 19.9 rising to 27 mg/dL, ALT 1566 U/L, Alk P 316 U/L], resolving rapidly upon stopping; enlarged lymph nodes in porta hepatis and ascites; biopsy showing reactive change, resolving with stopping celandine).
Conti E, De Checchi G, Mencarelli R, Pinato S, Rovere P. (2008). Lycopodium similiaplex-induced acute hepatitis: a case report. Eur J Gastroenterol Hepatol. (46 year old woman developed nausea and fatigue 8 weeks after starting L similiaplex solution [L serratum and Chelidonium majus] for insomnia [bilirubin 3.2 mg/dL, ALT 2364 U/L, Alk P 255 U/L], with resolution in 2 months of stopping).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to greater celandine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were attributed to greater celandine).
Tarantino G, Pezzullo MG, Dario di Minno MN, Milone F, Pezzullo LS, Milone M, Capone D. (2009). Drug-induced liver injury due to "natural products" used for weight loss: a case report. World J Gastroenterol. (22 year old woman developed jaundice, pruritus, fever and abdominal pain [bilirubin 7.5 g/dL, ALT 1686 U/L, Alk P 1229 U/L, eosinophils 7%], responding only partially to cholecystectomy and extraction of stones from the common bile duct, whereupon she was found to have been taking greater celandine and Lycopodium serratum).
Moro PA, Cassetti F, Giugliano G, Falce MT, Mazzanti G, Menniti-Ippolito F, Raschetti R, Santuccio C. (2009). Hepatitis from Greater celandine(Chelidonium majus L.): review of literature and report of a new case. J Ethnopharmacol. (Case report and review of 16 cases in the literature; 65 year old man developed jaundice one month after starting daily ingestion of tea made from greater celandine extract [Chelidonium majus] [bilirubin 6.4 mg/dL, ALT 4765 U/L], with resolution within 2 months of stopping).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; greater celandine is not discussed).
Teschke R, Glass X, Schulze J. (2011). Herbal hepatotoxicity by Greater Celandine (Chelidonium majus): causality assessment of 22 spontaneous reports. Regul Toxicol Pharmacol. (Analysis of 22 cases of liver injury attributed to greater celandine reported to the German Registry using RUCAM found only 8 to be probable: 3 men and 5 women, ages 32 to 66 years, with onset after 28 to 42 [mean = 36] days [bilirubin elevated in 7, ALT 420-2928 U/L, Alk P 256-408 U/L], all recovered).
Teschke R, Frenzel C, Glass X, Schulze J, Eickhoff A. (2012). Greater Celandine hepatotoxicity: a clinical review. Ann Hepatol. (Analysis of clinical features of 16 cases of hepatotoxicity attributed to greater celandine from the European literature; 6 men and 10 women, ages 32 to 69 years, onset after 3 weeks to 4.5 months, usually with a hepatocellular pattern of injury and resolving with stopping in all).
Teschke R, Glass X, Schulze J, Eickhoff A. (2012). Suspected Greater Celandine hepatotoxicity: liver-specific causality evaluation of published case reports from Europe. Eur J Gastroenterol Hepatol. (Among 21 published case reports of liver injury attributed to celandine, only 8 were scored as probable by the RUCAM system: 3 men and 5 women, ages 37 to 68 years, onset in 3-12 weeks [ALT 152-4765 U/L, Alk P 221-516 U/L], resolving in 1 to 5 months of stopping).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 15 publications on greater celandine).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury discusses the clinically apparent hepatotoxicity attributed to greater celandine, reported largely from Europe).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], including 28 of 66 cases [42%] attributed to greater celandine, and that these other diagnoses weakened the causality assessment in most instances).
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2014). Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; among 3 cases attributed to greater celandine, 1 rechallenge was considered negative and 1 uninterpretable).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 145 [16%] were attributed to herbal and dietary supplements, but none to greater celandine).
Yilmaz B, Yilmaz B, Aktaş B, Unlu O, Roach EC. (2015). Lesser celandine (pilewort) induced acute toxic liver injury: The first case report worldwide. World J Hepatol. (36 year old woman developed jaundice 10 days after starting drinking tea made from lesser [not greater] celandine also known as Ranunculus ficaria or “pilewort” [bilirubin 3.4 mg/dL, ALT 1830 U/L, Alk P 225 U/L], with rapid recovery upon stopping).
Frenzel C, Teschke R. (2016). Herbal hepatotoxicity: clinical characteristics and listing compilation. Int J Mol Sci. (Review of the challenges in the diagnosis of hepatotoxicity due to herbal products including problems of misidentifications, adulterants, impurities, range of clinical presentations, lack of diagnostic markers, and alternative diagnoses; an extensive compilation of herbs reported to have caused liver injury including greater celandine).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 6 publications of case reports and case series implicating greater celandine in causing liver injury).
Pantano F, Mannocchi G, Marinelli E, Gentili S, Graziano S, Busardò FP, di Luca NM. (2017). Hepatotoxicity induced by greater celandine (Chelidonium majus L.): a review of the literature. Eur Rev Med Pharmacol Sci. (Review of the published literature on liver injury from greater celandine).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], only one of which was attributed to greater celandine, a 37 year old man with hepatocellular injury that resulted in liver transplantation in 2012).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to greater celandine).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [n=91], green tea [90] Herbalife products [64], kava [62] and greater celandine [48]).

## OTHER REFERENCE LINKS

1 Recent References on Greater Celandine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Greater+Celandine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Greater Celandine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Greater+Celandine)